# Naxitamab

Short Chapter

[Preliminary review chapter based on the FDA Product Labeling and Integrated Review only.]

## OVERVIEW

### Introduction

Naxitamab is a monoclonal antibody to GD2 that is used in combination with granulocyte-macrophage colony stimulating factor to treat children with relapsed or refractory high risk neuroblastoma of the bone or bone marrow. Naxitamab therapy is associated with transient serum aminotransferase elevations during therapy but has not been linked to instances of clinically apparent liver injury.

### Background

Naxitamab (nax it’ a mab) is a humanized, cytolytic monoclonal antibody to glycolipid disialoganglioside (GD2), an adhesion molecule widely expressed on cell membranes of neuroectoderm derived tumors including neuroblastoma, the most common extra-cranial cancer of children. Naxitamab was found to be cytolytic to neuroblastoma cells in culture and resulted in objective responses in 34% to 45% of children and adults with refractory advanced neuroblastoma of bone and bone marrow. Naxitamab was granted accelerated approval in 2020 for treatment of children 1 year of age and older and adults with relapsed or refractory high risk neuroblastoma in the bone or more marrow. Naxitamab is available in solution in single dose vials of 40 mg in 10mL (4 mg/mL) under the brand name Danyelza. The recommended dose is 3 mg/kg/day (to a maximum of 150 mg/day) on days 1, 3, and 5 of 28-day cycles. Granulocyte-macrophage colony stimulatory factor (GM-CSF) should be given subcutaneously with each treatment cycle. In addition, premedication with acetaminophen, antihistamines, and corticosteroids is recommended to prevention serious infusion reactions. In prelicensure trials, adverse events were common and included infusion reactions, neurotoxicity, pain (abdominal, bone, neck, and extremity), neurologic toxicity to the eye (blurred vision, impaired vision, photophobia), tachycardia, hypertension, fatigue, nausea and vomiting, diarrhea, decreased appetite, rash, urticaria, fever, cough, peripheral edema, fatigue, irritability, and mental status changes. Serious adverse events associated with naxitamab therapy included severe neurotoxicity manifested by peripheral neuropathy, prolonged urinary retention, severe pain, transverse myelitis, and rare instances of reversible posterior leukoencephalopathy syndrome. Other potential severe adverse events included anaphylaxis, hypotension, bronchospasm, stridor, cardiac arrest, severe hypertension, myocarditis, and embryo-fetal toxicity. Obviously, naxitamab should only be administered by health care personnel with experience, expertise, and facilities capable of managing the complications of naxitamab therapy.

### Hepatotoxicity

Naxitamab was evaluated in small, prospective open label trials in children and adults with refractory neuroblastoma, a rare but often fatal cancer. Abnormal laboratory results were common during therapy including elevations in serum ALT levels in 55% of subjects which were 5 times ULN or greater than the upper limit of normal (ULN) in 9%. Nevertheless, there were no instances of serum aminotransferase elevations accompanied by jaundice, or suspected drug induced liver injury, and no subject discontinued therapy because of abnormal liver tests. Most of the abnormal liver test findings were not attributed to therapy. In assessing abnormal serum aminotransferases in children receiving cancer chemotherapy, it is worthwhile to review the premedications given, particularly of acetaminophen dose which should be limited to less than 75 mg per kilogram daily. Since its approval in 2020, there have been no published reports of clinically apparent liver injury attributable to naxitamab therapy, but clinical experience with its use has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of the frequent liver test abnormalities during naxitamab therapy are not known but may be due to the cytotoxic monoclonal antibody and low level expression of GD2 on hepatocytes. Some of the abnormalities are no doubt due to the underlying condition and other treatments administered. Naxitamab can cause hypersensitivity reactions including urticaria, rash, and anaphylaxis, and liver injury might be a part of a generalized immunoallergic reaction.

### Outcome and Management

The product label for naxitamab does not recommend monitoring of routine liver tests during therapy, and considerations of the severity of the underlying tumor and its poor prognosis generally outweigh concerns about serum aminotransferase elevations not accompanied by jaundice or symptoms of liver injury.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Naxitamab – Danyelza®

DRUG CLASS

Antineoplastic agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Naxitamab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Naxitamab | 1879925-92-4 (https://pubchem.ncbi.nlm.nih.gov/compound/Naxitamab) | Monoclonal Antibody | Not Available

## SELECTED BIBLIOGRAPHY

References updated: 12 July 2024

Abbreviations: ULN, upper limit of the normal range.

[Short Chapter information is based largely on FDA Product Labeling and the FDA Integrated Review accessible from the FDA website https://www.accessdata.fda.gov/scripts/cder/daf/index.cfm . All other references have not been fully reviewed and annotated.]
FDA. Integrated Review. 2020. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/761171Orig1s000MultidisciplineR.pdf (FDA summary data on the safety and efficacy of naxitamab, submitted in support of the application for approval as therapy of neuroblastoma in children, mentions that no significant trends were observed across cycles for clinical chemistry parameters associated with liver function tests and there was no indication of drug induced liver injury).
Markham A. Naxitamab: first approval. Drugs. 2021;81:291-296.33616889
Mora J, Castañeda A, Gorostegui M, Santa-María V, Garraus M, Muñoz JP, Varo A, et al. Naxitamab combined with granulocyte-macrophage colony- stimulating factor as consolidation for high-risk neuroblastoma patients in complete remission. Pediatr Blood Cancer. 2021;68:e29121.34022112
Mora J, Chan GC, Morgenstern DA, Nysom K, Bear MK, Tornøe K, Kushner BH. Outpatient administration of naxitamab in combination with granulocyte-macrophage colony-stimulating factor in patients with refractory and/or relapsed high-risk neuroblastoma: management of adverse events. Cancer Rep (Hoboken). 2023;6:e1627.35579862
Mora J, Castañeda A, Gorostegui M, Varo A, Perez-Jaume S, Simao M, Muñoz JP, et al. Naxitamab combined with granulocyte-macrophage colony-stimulating factor as consolidation for high-risk neuroblastoma patients in first complete remission under compassionate use-updated outcome report. Cancers (Basel). 2023;15:2535.37174002
Trovillion EM, Michael M, Jordan CC, Brown L, Phillips K, Oesterheld J, Saulnier-Sholler G. Guidelines for outpatient administration of naxitamab: Experience from Atrium Health Levine Children's Hospital. Cancer Med. 2024;13:e7045.38396377

## OTHER REFERENCE LINKS

1. Recent References on Naxitamab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Naxitamab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Naxitamab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Naxitamab)